# Slippery Elm

## OVERVIEW

### Introduction

Slippery elm (Ulmus rubra) is a broad leafed deciduous tree native to Eastern and Central United States and Canada, the inner bark of which is used orally to treat sore throat and gastrointestinal upset and topically for skin rash and irritation. Slippery elm preparations are generally recognized as safe and there is no evidence that it can cause elevations in liver related enzymes or clinically apparent liver injury.

### Background

Slippery elm (Ulmus rubra) is a broad leafed, medium sized, deciduous tree native to Eastern and Central United States and Canada. The inner bark of slippery elm, when stripped of the outer bark, can be used as a lozenge to treat sore throat, as a pill for gastrointestinal upset, and as a cream or ointment for skin rash and wound healing. Slippery elm resembles the American Elm (Ulmus Americana) but is less stately and less susceptible to Dutch Elm disease. Also known as red elm, it is called slippery because of the slippery texture of the inner bark when it is chewed or mixed with water. Its medicinal effects appear to be due to stimulation of mucous and saliva, which may alleviate sore or dry throat and coat irritated or ulcered esophageal or gastric mucosa. Slippery elm preparations were used in Native American traditional medicine for gastrointestinal and urinary tract disorders and topically for skin diseases. The active ingredients appear to be mucilages, but the inner bark is also rich in tannins and resins which are astringents and may account for some of its effects. While not approved as therapy for any disease or condition, over-the-counter preparations are sold as demulcents and for gastrointestinal upset. There is no reliable data on adverse events from slippery elm and it is designated as “generally recognized as safe” (GRAS). There have been no large scale clinical trials that have reported on adverse events associated with use of slippery elm preparations. Slippery elm has been linked to rare instances cutaneous allergic symptoms.

### Hepatotoxicity

While slippery elm is generally recognized as safe, it has not been formally assessed for hepatic adverse effects or elevations of serum aminotransferases, alkaline phosphatase or bilirubin levels. In addition, despite common use, there have been no published case reports of liver injury attributed to slippery elm. Large case series of liver injury due to herbal and dietary supplements do not mention or list slippery elm as an implicated cause of liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

Other names: Indian elm, Moose Elm, Orme, Sweet elm, Ulmus fulva.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Slippery Elm – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/978.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Slippery Elm | 90028-27-6 | Not applicable | SID: 135275635

## ANNOTATED BIBLIOGRAPHY

References updated: 05 January 2024

Abbreviations: DILI, drug induced liver injury; HDS, herbal and dietary supplements; LDL-C, low density lipoprotein cholesterol.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not slippery elm).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of slippery elm).
Slippery Elm. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 755-756. (Compilation of short monographs on herbal medications and dietary supplements, mentions that “no health hazards or side effects are known” to be associated with its use).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to slippery elm). 19650152
Cho AR, Lee SY, Cho YH, Kim CM, Kim SG. Effects of 4-week intervention with Ulmus macrocarpa Hance Extract on immune function biomarkers in healthy adults: a randomized controlled trial. Evid Based Complement Alternat Med. 2018;2018:5690816. (Among 50 healthy controls treated with an Ulmus macrocarpa extract [500 mg] or placebo once daily for 4 weeks, minor changes occurred in serum cytokine levels but “No change in liver function, renal function or CK were observed in either group”). 29681977
Lee YL, Lee SY. Potential lipid-lowering effects of Ulmus macrocarpa Hance extract in adults with untreated high low-density lipoprotein cholesterol concentrations: A randomized double-blind placebo-controlled trial. Front Med (Lausanne). 2022;9:1000428. (Among 80 patients with elevated low density lipoprotein cholesterol [LDL-C] levels were treated with an extract of Ulmus macrocarpa [500 mg daily] or placebo for 12 weeks, LDL-C levels deceased more with U. macrocarpa than placebo [-23 vs -9 mg/dL] and there were no side effects and no significant changes in liver enzyme concentrations). 36388925
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention slippery elm). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention slippery elm). 23121117
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of slippery elm). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to slippery elm). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss slippery elm). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of slippery elm). 29307848
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; slippery elm is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; slippery elm is not mentioned). 33434654

## OTHER REFERENCE LINKS

Recent References on Slippery Elm: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Slippery+Elm+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Slippery Elm: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Slippery+Elm)